# Tenapanor

## OVERVIEW

### Introduction

Tenapanor is a small molecular inhibitor of the sodium/hydrogen ion exchanger-3 (NHE3) used to treat constipation predominant irritable bowel syndrome (IBS). Tenapanor has minimal systemic absorption and has not been associated with serum enzyme elevation during therapy nor has it been linked to cases of clinically apparent liver injury.

### Background

Tenapanor (ten a’ pan or) is a small molecule inhibitor of the sodium-hydrogen exchanger isoform 3 (NHE3) which is responsible for sodium absorption in the intestine with resultant passive uptake of water. Inhibition of the transporter results in an increase in osmotic secretion of water, shortening of intestinal transit time and softening of stool consistency. On the other hand, inhibition of the exchanger can also result in diarrhea and possibly dehydration. Tenapanor acts locally and has minimal absorption. Tenapanor was found to improve frequency [struck: numbers] and completeness of bowel movements and symptoms of bloating and distension in patients with constipation-predominant IBS and was approved for this indication in adults in 2019. Tenapanor has also been evaluated as a means of reducing hyperphosphatemia in patients with chronic renal failure on dialysis, but has yet to be given approval for that indication. Tenapanor is available in tablets of 50 mg under the brand name Ibsrela, the recommended dose being 50 mg twice daily taken before breakfast and before dinner. Tenapanor has not been approved for treatment of children and is contraindicated in children below the age of 6 because of the risk of dehydration. Common side effects include diarrhea, abdominal distension, flatulence, and dizziness. Rare, but potentially severe adverse events include severe diarrhea and dehydration. Tenapanor has embryo-fetal toxicity in animals and should not be used in pregnancy.

### Hepatotoxicity

When given orally, tenapanor has minimal systemic absorption and has not been associated with elevations in serum enzymes or bilirubin or with instances of clinically apparent liver injury. Since approval and general availability of tenapanor, there have been no published reports of liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Tenapanor has minimal systemic absorption and has not been linked to instances of liver injury.

Drug Class: Gastrointestinal Agents, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tenapanor – Ibsrela®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tenapanor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tenapanor | 1234365-97-9 | C50-H66-Cl4-N8-O10-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 30 April 2023

Abbreviations: IBS, irritable bowel syndrome; NHE3, sodium-hydrogen exchanger isoform 3.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of tenapanor).
Sharkey KA, MacNaughton WK. Gastrointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/211801Orig1s003.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; provides results from pharmacokinetic studies that demonstrated minimal or no detectable serum tenapanor levels after oral administration even in patients with significant hepatic and renal dysfunction or when given with strong inhibitors and inducers of cytochrome P450 [CYP] enzymes).
Chey WD, Lembo AJ, Rosenbaum DP. (2017). Tenapanor treatment of patients with constipation-predominant irritable bowel syndrome: a phase 2, randomized, placebo-controlled efficacy and safety trial. Am J Gastroenterol. (Among 356 adults with constipation-predominant irritable bowel syndrome treated with tenapanor [5, 20 or 50 mg] twice daily for 12 weeks, response rates were highest with the 50 mg dose [61% vs 34% with placebo] while diarrhea arose in 11% of subjects, “There were no clinically meaningful changes from baseline in laboratory parameters”).
Block GA, Rosenbaum DP, Yan A, Chertow GM. (2019). Efficacy and safety of tenapanor in patients with hyperphosphatemia receiving maintenance hemodialysis: a randomized phase 3 trial. J Am Soc Nephrol. (Among 219 adults with chronic renal failure on maintenance hemodialysis treated with 3, 10 or 30 mg of tenapanor twice daily for 8 weeks, serum phosphate levels fell in all three groups, but diarrhea was a frequent side effect [30%-50%]; no mention of ALT elevations or hepatotoxicity).
Markham A. (2019). Tenapanor: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of tenapanor shortly after its approval for use in the US, discusses the gastrointestinal side effects but does not mention ALT elevations or hepatotoxicity).
Chey WD, Lembo AJ. (2020). Rosenbaum aDP. Efficacy of tenapanor in treating patients with irritable bowel syndrome with constipation: a 12-week, placebo-controlled phase 3 trial (T3MPO-1). Am J Gastroenterol. (Among 606 adults with constipation-predominant IBS treated with tenapanor [50 mg] or placebo twice daily for 12 weeks, tenapanor treated patients had greater increases in complete spontaneous bowel movements and more reductions in abdominal symptoms, while adverse events included diarrhea [15% vs 2%] and nausea [2.6% vs 1.7%], discontinuation rates were 7.4% vs <1%, and there were no drug related deaths or serious adverse events and “no notable changes from baseline were observed in laboratory parameters”).
Block GA, Bleyer AJ, Silva AL, Weiner DE, Lynn RI, Yang Y, Rosenbaum DP, et al. Safety and efficacy of tenapanor for long-term serum phosphate control in maintenance dialysis: a 52-week randomized phase 3 trial (PHREEDOM). Kidney360. 2021;2:1600-1610. (Among 564 patients with chronic renal failure on maintenance dialysis with hyperphosphatemia treated with either tenapanor or sevelamer carbonate for 26 weeks, those on tenapanor with improvements in serum phosphate levels being later re-randomized to continue therapy or stop tenapanor, side effects during therapy were predominantly gastrointestinal with diarrhea arising in 52% taking tenapanor, being severe in 6% and resulting in withdrawal in 16%; no mention of ALT levels or hepatotoxicity).
Chey WD, Lembo AJ, Yang Y, Rosenbaum DP. (2021). Efficacy of tenapanor in treating patients with irritable bowel syndrome with constipation: a 26-week, placebo-controlled phase 3 trial (T3MPO-2). Am J Gastroenterol. (Among 593 adults with constipation-predominant IBS treated with tenapanor [50 mg] or placebo twice daily for 26 weeks, response rates were higher for tenapanor [37% vs 24%] and the main side effect was diarrhea [16% vs 4%], which led to early discontinuation in 6.5% vs 0.7%, and “Generally, there was no evidence of clinically significant differences between treatment groups in electrolytes and other laboratory parameters”).
(2022). Tenapanor (Ibsrela) for irritable bowel syndrome with constipation. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of tenapanor shortly after its approval for use in adults with constipation-predominant IBS, discusses the side effects of diarrhea, abdominal distension, flatulence, and dehydration, but does not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Tenapanor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tenapanor+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tenapanor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tenapanor)